# Zafirlukast

## OVERVIEW

### Introduction

Zafirlukast is an orally available leukotriene receptor antagonist which is widely used for the prophylaxis and chronic treatment of asthma. Zafirlukast has been linked to rare, but occasionally severe cases of acute liver injury.

### Background

Zafirlukast (za" fir loo' kast) is a leukotriene receptor antagonist that binds to the CysLT1 and CysLT2 receptors, thereby interfering with inflammatory pathways that are involved in the pathogenesis of asthma and allergic rhinitis. Pretreatment with single oral doses of zafirlukast inhibits bronchoconstriction and the early-phase and part of the late-phase inflammatory reactions in asthma. Zafirlukast was approved for use in the treatment of asthma in the United States in 1996, and it continues to be widely used with more than 2 million prescriptions filled yearly. Other leukotriene receptor antagonists include montelukast and pranlukast, but only montelukast is also available in the United States. Current indications include the prophylaxis and chronic treatment of asthma in adults and children (above the age of 5). Zafirlukast is available in 10 and 20 mg tablets generically and under the brand name Accolate. The recommended dosage of zafirlukast in adults and children >12 years is 20 mg twice daily. The recommended dose in children 5 to 11 years is 10 mg twice daily. Common side effects include nausea, diarrhea, dyspepsia, abdominal pain, headache, dizziness, myalgias, and fever.

### Hepatotoxicity

Prospective studies have shown that ALT elevations occur in 1.5% of patients receiving zafirlukast, most of which are mild, asymptomatic and self limited even with continuing therapy. A similar rate of transient ALT elevations is often found in placebo recipients. Clinically apparent liver disease from zafirlukast is rare, but many convincing cases have been reported, several of which were severe and resulted in hepatic failure, need for liver transplantation or death. The onset of symptoms of liver injury is typically within 2 to 6 months of starting therapy, but cases with longer latency periods have been reported (8-13 months). Symptoms include fatigue, nausea, and right upper quadrant pain followed by dark urine, jaundice and pruritus. The pattern of liver enzyme elevation is usually hepatocellular and resembles acute viral hepatitis. Eosinophilia is common but immunoallergic features are usually not prominent and autoantibodies are uncommon (eosinophilia may be due to the underlying allergic asthmatic condition). Fatal cases have been described. Reexposure can lead to more rapid and severe reappearance of injury and should be avoided. Zafirlukast can also cause systemic vasculitis and eosinophilia (Churg-Strauss Syndrome) which may be accompanied by hepatic involvement and mild enzyme elevations.

Likelihood score: C (probable cause of clinical apparent liver injury).

### Mechanism of Hepatotoxicity

The mechanism of hepatic injury due to zafirlukast is not known but it is clearly idiosyncratic. The extensive hepatic metabolism of zafirlukast by the cytochrome P450 (CYP2C9) system suggests that injury may be a result of a hepatotoxic or immunogenic intermediate.

### Outcome and Management

Monitoring of routine liver tests for liver injury is recommended but has not been shown to be effective in preventing the rare instances of hepatic injury due to zafirlukast and the optimal timing and frequency of such testing is not well define. Patients should be alerted to the signs and symptoms of liver injury and stop therapy or be seen quickly if they occur. Typically, symptoms and liver enzymes abnormalities resolve rapidly after stopping zafirlukast. In rare cases, patients have either presented with fulminant hepatitis or progressed to hepatic failure, liver transplantation and death. Rechallenge leads to prompt recurrence and should be avoided. Switching to another leukotriene receptor antagonist such as montelukast or to zileuton, a 5-lipoxygenase inhibitor with a related mechanism of action, is usually possible but should be done with caution.

Drug Class: Antiasthmatic Agents

Other Drugs in the Subclass, Leukotriene Receptor Antagonists: Montelukast

## CASE REPORTS

### Case 1. Acute hepatitis related to zafirlukast use.

[Modified from: Moles JM, Primo J, Fernandez JM, Hinojosa JE. Acute hepatocellular injury associated with zafirlukast. J Hepatol 2001; 35: 541-2. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/11682044)]

A 63 year old woman with asthma developed fatigue and anorexia 8 weeks after adding zafirlukast (20 mg twice daily) to a chronic regimen of various inhalants including salbutamol, fomoterol and budesonide. Two weeks later she noted dark urine and jaundice, but waited another two weeks before seeking medical advice. She had no history of liver disease and serum aminotransferase levels had been normal in the past. She had no risk factors for viral hepatitis, did not use alcohol, and took no other medications. Her past medical history included gall bladder disease leading to a cholecystectomy 4 years previously. On examination, she was jaundiced but had no fever, rash, hepatomegaly or signs of chronic liver disease. Laboratory tests showed a total bilirubin of 4.5 mg/dL, ALT 999 U/L, AST 980 U/L, alkaline phosphatase 323 U/L and GGT 258 (normal <50) U/L. The prothrombin time was normal and tests for acute hepatitis A, B and C were negative as were autoantibodies. An abdominal ultrasound was normal. Zafirlukast was discontinued on admission and she improved rapidly (Table). Liver biopsy was not done. Symptoms and jaundice resolved within 2 weeks and liver tests were normal when she was seen 3 months after stopping.

#### Key Points

Medication: | Zafirlukast (20 mg twice daily)
Pattern: | Hepatocellular (R=19.2)
Severity: | 3+ (hospitalization for jaundice)
Latency: | 8 weeks to symptoms, 10 weeks to jaundice
Recovery: | 3 months
Other medications: | Salmeterol and fomoterol aerosol and budesonide inhaler

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
8 weeks | Anorexia and fatigue
10 weeks | Dark urine and jaundice
12 weeks | 0 | 999 | 323 | 4.5 | Zafirlukast stopped
13 weeks | 7 days | 918 | 683 | 2.6 | Normal ultrasound
14 weeks | 18 days | 560 | 729 | 1.6
5 months | 2 months | 130 | 303 | 1.0 | Asymptomatic
6 months | 3 months | 21 | 249 | 0.6
9 months | 6 months | 27 | 260 | 0.7
Normal Values | | <40 | <280 | <1.2

#### Comment

This patient developed an acute hepatitis-like syndrome 2 months after starting zafirlukast for chronic asthma, which began to resolve within a week of stopping the suspected agent. She was taking no other medications except inhalants which she had used for years, and clinical evaluation ruled out other common causes of liver injury. Zafirlukast has been linked to several instances of acute liver injury usually arising within 2 to 6 months of starting and presenting with jaundice and a hepatocellular pattern of liver injury. The course is usually self limiting, but several instances of acute liver failure leading to death or emergency liver transplantation have been published.

### Case 2. Acute liver injury due to zafirlukast.

[Modified from: Reinus JF, Persky S, Burkiewicz JS, Quan D, Bass NM, Davern TJ. Severe liver injury after treatment with the leukotriene receptor antagonist zafirlukast. Ann Intern Med 2000; 133: 964-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/11119397)]

A 42 year old woman with chronic sinusitis and asthma was found to have abnormal serum enzymes 9 months after she was started on zafirlukast. She had no symptoms, but therapy was stopped and she was switched to montelukast, on which her serum aminotransferase levels fell to normal. Zafirlukast was restarted, but 2 months later she developed symptoms and jaundice. When seen one month later, she was jaundiced and had marked serum aminotransferase elevations (Table). She had no history of exposure to viral hepatitis and did not drink alcohol. She recovered slowly, jaundice resolved within 2 months and serum enzyme elevations within 5 months of stopping.

#### Key Points

Medication: | Zafirlukast (20 mg twice daily)
Pattern: | Hepatocellular
Severity: | 3+ (hospitalization for jaundice)
Latency: | Initially, 9 months, 2 months on rechallenge
Recovery: | 5 months on rechallenge
Other medications: | Salmeterol aerosol and fluticasone propionate inhaler and nasal spray

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
Started zafirlukast 20 mg twice daily
9 months | 0 | 295 | | 0.7 | Started montelukast
13 months | 4 months | Normal | | 0.7
Resumed zafirlukast 20 mg twice daily
2 months | 0 | Symptoms and jaundice: zafirlukast stopped
3 months | 1 month | 1566 | | 6.2
4 months | 2 months | 270 | | 3.1
5 months | 3 months | | | 1.4
6 months | 4 months | | | 1.2
7 months | 5 months | Normal | | 0.5 | Asymptomatic
Normal Values | | <35 | <130 | <1.2

* Selected values estimated from Figure.

#### Comment

The initial ALT elevations had several possible explanations, but the reappearance of hepatocellular injury upon rechallenge is firm evidence of the role of zafirlukast. Interestingly, she tolerated montelukast, another leukotriene receptor antagonist with a somewhat similar chemical structure, without evidence of liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Zafirlukast – Generic, Accolate®

DRUG CLASS

Antiasthma Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=zafirlukast)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Zafirlukast | 107753-78-6 | C31-H33-N3-O6-S | Zafirlukast Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 04 June 2019

Zimmerman HJ. Respiratory supportive drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p. 717. (Expert review of hepatotoxicity published in 1999; mentions that theophylline has been incriminated in hepatic injury rarely; no mention of montelukast, zafirlukast or zileuton).
Lewis JH. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. pp. 389-90. (Expert review of liver injury caused by leukotriene receptor antagonists mentions that there were no reports of clinically apparent liver injury during premarketing studies of zafirlukast, but that more than 100 reports of clinically apparent injury appeared thereafter, at least 14 resulting in liver failure).
Barnes PJ. Pulmonary pharmacology. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 727-30. (Textbook of pharmacology and therapeutics).
Drazen JM, Israel E, O’Byrne PM. Treatment of asthma with drugs modifying the leukotriene pathway. N Engl J Med 1999; 340: 197-206. (Review article on leukotriene pathway in asthma and rhinitis and efficacy and safety of montelukast, zafirlukast and zileuton; mentions that abnormal ALT elevations can occur). 9895400
Gozalo Reques F, Estrada Rodriguez JL. Tolerability of leukotriene modifiers in asthma: a review of clinical experience. Biodrugs 1999; 11: 385-94. (Review of safety of leukotriene antagonists without new information). 18031150
Grossman J, Smith LJ, Wilson AM, Thyrum PT. Long-term safety and efficacy of zafirlukast in the treatment of asthma: interim results of an open-label extension trial. Ann Allergy Asthma Immunol 1999; 82: 361-9. (Open labeled continuation of controlled trial of zafirlukast for 39 weeks; among 443 patients, 4.4% had ALT elevations, but peak value 340 U/L and all were self limited; one patient was withdrawn because of ALT elevations). 10227334
Grieco AJ, Burstein-Stein J. Oral montelukast versus inhaled salmeterol to prevent exercise-induced bronchoconstriction. Ann Intern Med 2000; 133: 392. (68 year old woman developed jaundice 4 months after starting zafirlukast [bilirubin 21.1 mg/dL, ALT 1217 U/L, Alk P 225 U/L], resolving upon stopping). 10979888
Reinus JF, Persky S, Burkiewicz JS, Quan D, Bass NM, Davern TJ. Severe liver injury after treatment with the leukotriene receptor antagonist zafirlukast. Ann Intern Med 2000; 133: 964-8. (Three patients developed jaundice 5, 6 and 9 months after starting zafirlukast [peak bilirubin 6.2, 39.1 and 20.3 mg/dL, ALT 1750, 1157, and 1212 U/L, Alk P not given], one patient developed acute liver failure and 2 recovered within 4 months of stopping: Case 2). 11119397
Actis GC, Morgando A, Lagget M, David E, Rizzetto M. Zafirlukast-related hepatitis: report of a further case [Letter]. J Hepatol 2001; 35: 539-41. (54 year old man developed jaundice 8 months after starting zafirlukast [bilirubin 3.9 mg/dL, ALT 661, and Alk P 135 U/L] with prolonged course despite corticosteroids, histology revealed severe injury with collapse). 11682043
Danese S, De Vitis I, Gasbarrini A. Severe liver injury associated with zafirlukast [Letter]. Ann Intern Med 2001; 135: 930. (55 year old woman developed severe hepatitis 5 months after starting zafirlukast [bilirubin not given, ALT 2113 U/L, GGT 15 times ULN], there was a delay in stopping therapy and liver biopsy showed submassive necrosis and recovery was slow). 11712893
Molés JR, Primo J, Fernández JM, Hinojosa JE. Acute hepatocellular injury associated with zafirlukast. J Hepatol 2001; 35: 541-2. (63 year old woman developed jaundice 2 months after starting zafirlukast [bilirubin 4.5 mg/dL, ALT 999 U/L, Alk P 683 U/L, GGT 258 U/L], resolving within 3 months of stopping: Case 1). 11682044
Spector SL; Antileukotriene Working Group. Safety of antileukotriene agents in asthma management. Ann Allergy Asthma Immunol 2001; 86 (6 Suppl 1): 18-23. (Review of side effects of antileukotrienes in premarketing studies, ALT elevations found in 1.4% of subjects on zafirlukast vs 1.1% on placebo; in 2.1% on montelukast vs 2.0% on placebo; and in 4.6% of zileuton recipients treated for a year [>3 times ULN; 3 had hyperbilirubinemia] vs 1.1% of controls). 11426912
Torres M, Reddy KR. Severe liver injury. Ann Intern Med. 2001; 135: 550. (36 year old woman developed jaundice 13 months after starting zafirlukast [peak bilirubin 28 mg/dL, ALT 3135 U/L, Alk P not given], followed by liver failure and emergency liver transplantation). 11578163
Soy M, Ozer H, Canataroglu A, Gumurdulu D, Erken E. Vasculitis induced by zafirlukast therapy. Clin Rheumatol 2002; 21: 328-9. (54 year old man developed purpura, malaise, pleural effusions and atectasis 2 weeks after starting zafirlukast [bilirubin normal, ALT 98 U/L, Alk P 780 U/L, 35% eosinophils], improving upon stopping drug and use of corticosteroids, felt to be Churg-Straus syndrome). 12189465
Su CW, Wu JC, Huang YH, Huang YS, Chang FY, Lee SD. Zafirlukast-induced acute hepatitis. Zhonghua Yi Xue Za Zhi(Taipei) 2002; 65: 553-6. (69 year old woman developed jaundice 3 months after starting zafirlukast [bilirubin 18.2 rising to 34.8 mg/dL, ALT 481 U/L, Alk P 346 U/L], resolving within 3 months of stopping). 12583521
Davern TJ, Bass NM. Leukotriene antagonists. Clin Liver Dis 2003; 7: 501-12, viii. (Review of literature on hepatotoxicity of leukotriene inhibitors; in premarketing studies, 1.5% of 4058 of zafirlukast vs 1.1% of placebo recipients had ALT elevations, none serious and all transient; review of literature identified 9 cases of zafirlukast hepatotoxicity, 7 with jaundice, 3 with rash and eosinophilia, arising after 1.5 to 13 months, with liver transplantation required in two). 12879996
Wooltorton E. Asthma drug zafirlukast (Accolate): serious hepatic events. CMAJ 2004; 170: 1668. (Editorial on zafirlukast and its linkage to serious liver injury). 15159361
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, one case was attributed to zafirlukast, but no other antiasthma medications mentioned). 15390328
Chohnabayashi N, Sugiura R, Nishimura N. [Adverse effects of leukotriene-antagonists] Nippon Rinsho 2007; 65 Suppl 8: 272-6. Japanese. (Review article on adverse events of leukotriene antagonists including montelukast, zafirlukast and pranlukast). 18072343
Twaites BR, Wilton LV, Shakir SA. Safety of zafirlukast. Results of a postmarketing surveillance study on 7976 patients in England. Drug Saf 2007; 30: 419-29. (Database of UK medical practice with questionnaire requesting information on zafirlukast treated patients, 7976 forms returned from 21,557 requests; 61% of physicians considered it effective, 53% of patients were treated for >6 months; 152 adverse events were reported in 120 patients [1.5%] including 34 hepatic events [4 with jaundice, 2 with hepatitis], but none were fatal and the authors concluded that “none of the events were serious”). 17472420
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to an antiasthma medication). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 1 due to zafirlukast, but none to montelukast or zileuton). 20949552
Agarwal VK, McHutchison JG, Hoofnagle JH; Drug-Induced Liver Injury Network. Important elements for the diagnosis of drug-induced liver injury. Clin Gastroenterol Hepatol 2010; 8: 463-70. (Review of the completeness of documentation of drug induced liver disease in published case reports of 6 different drugs [including 8 reports of zafirlukast and 4 of montelukast hepatotoxicity] identified important missing data in most reports). 20170750
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-Induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to zafirlukast or other antiasthma medications). 23419359
Aagaard L, Hansen EH. Adverse drug reactions associated with asthma medications in children: systematic review of clinical trials. Int J Clin Pharm 2014; 36: 243-52. (Systematic review of adverse events reported in controlled trials of asthma medications including zafirlukast in children; no mention of ALT elevations or hepatotoxicity). 24562976
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, montelukast was implicated in 4 cases, but zafirlukast and other antiasthma agents were not implicated in any cases). 25754159
Leung JS, Johnson DW, Sperou AJ, Crotts J, Saude E, Hartling L, Stang A. A systematic review of adverse drug events associated with administration of common asthma medications in children. PLoS One 2017; 12: e0182738. (Systematic review of adverse events in reported in 46 clinical studies of commonly used asthma medications including 25 events associated with leukotriene antagonists affecting 9 organ systems; hepatotoxicity not mentioned). 28793336
Drugs for asthma. Med Lett Drugs Ther 2017; 59 (1528): 139-146. (Concise review of medications used for asthma including the leukotriene modifiers; mentions that zafirlukast and zileuton have been reported to cause life-threatening hepatic injury and that monitoring of liver tests during therapy is recommended). 28880849

## OTHER REFERENCE LINKS

1. Recent References on Zafirlukast: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Zafirlukast/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Zafirlukast: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Zafirlukast)